# Ixabepilone

## OVERVIEW

### Introduction

Ixabepilone is a semisynthetic epothilone analogue that acts to stabilize microtubules thereby preventing mitosis and causing growth arrest in cancer cells. Ixabepilone is approved for use in refractory cases of advanced breast cancer. Its use is associated with a low rate of serum enzyme elevation, but ixabepilone has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Ixabepilone (ix" a bep' i lone) is semisynthetic analogue of epothilone B, epothilones being cytotoxic macrolides that cause cell growth arrest by binding to microtubules and preventing mitosis. Ixabepilone is similar in activity to taxanes, but differs structurally and is not affected by taxane resistance. Therapy with ixabepilone has been shown to prolong relapse-free as well as overall survival in women with locally advanced or metastatic breast cancer that has not responded or has relapsed after standard therapies such as with taxanes, capecitabine and anthracyclines. Ixabepilone was approved for use in the United States in 2007 and current indications are for locally advanced or metastatic breast cancer given as monotherapy or in combination with capecitabine after failure of other treatments. Ixabepilone is available in vials of 15 and 45 mg supplied with diluent under the brand name Ixempra. The recommended starting dose is 40 mg/m^2^ intravenously [infused over 3 hours] every 3 weeks. Common side effects include peripheral neuropathy, fatigue, muscle and joint pains, stomatitis, diarrhea, anorexia, weight loss, constipation, hair loss, hand-foot syndrome and myelosuppression. Rare, but potentially serious side effects include severe peripheral neuropathy, neutropenia, hypersensitivity reactions and fetal toxicity. Toxicity of ixabepilone is greater in patients with preexisting liver abnormalities which should trigger use of lower doses when given as monotherapy and avoidance of its use in combination with capecitabine.

### Hepatotoxicity

In preregistration controlled trials, serum aminotransferase elevations and other liver test abnormalities were rarely mentioned. A high proportion of patients treated had mild-to-moderate serum enzyme elevations at the time of starting ixabepilone, probably because of hepatic metastases and the use of other antineoplastic agents. During ixabepilone therapy, worsening of serum enzyme elevations occurred in up to 15% of patients, but ALT elevations above 5 times the upper limit of normal were rare, and there were no reports of severe hepatic adverse events or discontinuations because of enzyme elevations or clinically apparent liver disease. Nevertheless, jaundice and acute liver failure as well as elevations in serum ALT, AST, alkaline phosphatase, and bilirubin are mentioned as occurring in clinical trials in the product label. Since the approval and more widescale use of ixabepilone, there have been no publications or descriptions of the clinical features of hepatotoxicity with jaundice associated with its use. Thus, clinically apparent liver injury probably occurs in a small proportion of patients receiving ixabepilone, but its relationship with the drug is unclear.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver enzyme elevations that occur during enzalutamide therapy is unknown. Ixabepilone is extensively metabolized in the liver predominantly by CYP 3A4 and 2D6 and is a strong inducer of CYP 3A4 and a moderate inducer of 2D6. Ixabepilone is susceptible to drug-drug interactions with inhibitors, inducers or substrates of these microsomal enzymes.

### Outcome and Management

The liver injury linked to ixabepilone therapy has been generally mild, consisting of transient and asymptomatic elevations in serum aminotransferase levels. Ixabepilone has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between ixabepilone and other therapies of advanced or metastatic breast cancer.

Drug Class: Antineoplastic Agents, Breast Cancer Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ixabepilone – Ixempra®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ixabepilone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ixabepilone | 219989-84-1 | C27-H42-N2-O5-S | Ixabepilone Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 January 2017

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of ixabepilone).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam, Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; ixabepilone is not discussed).
Moy B, Lee RJ, Smith M. Hormone therapy in prostate cancer. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1763-9. (Textbook of pharmacology and therapeutics).
Low JA, Wedam SB, Lee JJ, Berman AW, Brufsky A, Yang SX, Poruchynsky MS, et al. Phase II clinical trial of ixabepilone (BMS-247550), an epothilone B analog, in metastatic and locally advanced breast cancer. J Clin Oncol 2005; 23: 726-34. (Among 37 women with metastatic breast cancer not responding to taxanes who were treated with ixabepilone [6 mg/m^2^ daily for 5 days every 3 weeks], the objective response rate was 22% and moderate-to-severe side effects included neutropenia, fatigue, diarrhea, nausea, myalgia and neuropathy; there were no liver related discontinuations). 15837987
Thomas E, Tabernero J, Fornier M, Conté P, Fumoleau P, Lluch A, Vahdat LT, et al. Phase II clinical trial of ixabepilone (BMS-247550), an epothilone B analog, in patients with taxane-resistant metastatic breast cancer. J Clin Oncol 2007; 25: 3399-406. (Among 49 women with refractory, metastatic breast cancer treated with ixabepilone, the overall response rate was 12% [partial responses only] and toxicities were frequent, but "manageable and mostly mild"; "hepatic" adverse events occurred in 6% of patients, but no details provided). 17606975
Vansteenkiste J, Lara PN Jr, Le Chevalier T, Breton JL, Bonomi P, Sandler AB, Socinski MA, et al. Phase II clinical trial of the epothilone B analog, ixabepilone, in patients with non small-cell lung cancer whose tumors have failed first-line platinum-based chemotherapy. J Clin Oncol 2007; 25: 3448-55. (Among 201 patients with non-small cell lung cancer who were refractory to standard therapy and were treated with ixabepilone, objective response rates were low and adverse side effects were common; no mention of ALT elevations or hepatotoxicity). 17606973
Denduluri N, Low JA, Lee JJ, Berman AW, Walshe JM, Vatas U, Chow CK, et al. Phase II trial of ixabepilone, an epothilone B analog, in patients with metastatic breast cancer previously untreated with taxanes. J Clin Oncol 2007; 25: 3421-7. (Among 23 women with refractory metastatic breast cancer treated with ixabepilone [6 mg/m^2^ for 5 days every 3 weeks], partial response rates were 57% and side effects included neuropathy, fatigue and neutropenia; no mention of ALT elevations or hepatotoxicity). 17606971
Roché H, Yelle L, Cognetti F, Mauriac L, Bunnell C, Sparano J, Kerbrat P, et al. Phase II clinical trial of ixabepilone (BMS-247550), an epothilone B analog, as first-line therapy in patients with metastatic breast cancer previously treated with anthracycline chemotherapy. J Clin Oncol 2007; 25: 3415-20. (Among 65 women with advanced, refractory breast cancer treated with ixabepilone [40 mg/m^2^ every 3 weeks], the objective response rate was 42% and most adverse events were "manageable"; no mention of ALT elevations or hepatotoxicity). 17606972
Perez EA, Lerzo G, Pivot X, Thomas E, Vahdat L, Bosserman L, Viens P, et al. Efficacy and safety of ixabepilone (BMS-247550) in a phase II study of patients with advanced breast cancer resistant to an anthracycline, a taxane, and capecitabine. J Clin Oncol 2007; 25: 3407-14. (Among 126 patients with advanced, refractory breast cancer treated with ixabepilone [40 mg/m^2^ every 3 weeks] for 1 to 16 cycles, the objective response rate was 12% and toxicity was "manageable and primarily" mild-to-moderate; no mention of ALT elevations or hepatotoxicity). 17606974
Pivot X, Dufresne A, Villanueva C. Efficacy and safety of ixabepilone, a novel epothilone analogue. Clin Breast Cancer 2007; 7: 543-9. (Review of the development, structure, mechanism of action, preclinical and clinical efficacy and side effects, focusing upon neuropathy, myelosuppression, and hypersensitivity reactions; no mention of ALT elevations or hepatotoxicity). 17509162
Bunnell C, Vahdat L, Schwartzberg L, Gralow J, Klimovsky J, Poulart V, Peck R, et al. Phase I/II study of ixabepilone plus capecitabine in anthracycline-pretreated/resistant and taxane-resistant metastatic breast cancer. Clin Breast Cancer 2008; 8: 234-41. (Among 106 women with metastatic, refractory breast cancer treated with ixabepilone and capecitabine in two different dose schedules, the overall response rate was 30% and 47% and side effects included hand foot syndrome, fatigue, myalgia, nausea, neuropathy, diarrhea and neutropenia; no mention of ALT elevations or hepatotoxicity). 18650153
Ixabepilone (Ixempra) for breast cancer. Med Lett Drugs Ther 2008; 50 (1278): 7-8. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ixabepilone as therapy of breast cancer shortly after its approval in the US; mentions side effects of peripheral neuropathy, fatigue, myalgia, alopecia, nausea, stomatitis, diarrhea and muscle pain as well as episodes of neutropenia). 18219261
Nimeiri HS, Singh DA, Kasza K, Taber DA, Ansari RH, Vokes EE, Kindler HL. The epothilone B analogue ixabepilone in patients with advanced hepatobiliary cancers: a trial of the University of Chicago Phase II Consortium. Invest New Drugs 2010; 28: 854-8. (Among 54 patients with advanced hepatobiliary cancers treated with ixabepilone [40 mg/m^2^ every 3 weeks], the objective response rate was only 8.5% and severe side effects included neutropenia, fatigue, hypersensitivity reactions and sensory neuropathy; no mention of serum enzyme elevations or worsening of liver disease). 19669700
Huang H, Menefee M, Edgerly M, Zhuang S, Kotz H, Poruchynsky M, Huff LM, et al. A phase II clinical trial of ixabepilone (Ixempra; BMS-247550; NSC 710428), an epothilone B analog, in patients with metastatic renal cell carcinoma. Clin Cancer Res 2010; 16: 1634-41. (Among 87 patients with metastatic renal cell carcinoma treated with ixabepilone, the overall response rate was 13% and adverse events included neuropathy [59%], alopecia [70%], severe neutropenia [11%] and febrile neutropenia [3.4%], no mention of ALT elevations or hepatotoxicity). 20179242
McMeekin S, Dizon D, Barter J, Scambia G, Manzyuk L, Lisyanskaya A, Oaknin A, et al. Phase III randomized trial of second-line ixabepilone versus paclitaxel or doxorubicin in 9 with advanced endometrial cancer. Gynecol Oncol 2015; 138: 18-23. (Among 496 women with advanced or metastatic endometrial cancer treated with ixabepilone or standard therapy [doxorubicin or paclitaxel] every 21 days, time of objective response was less with ixabepilone [10.3 vs 13.3 months] and adverse events were more frequent including peripheral neuropathy [44% vs 26%]; no mention of ALT elevations or hepatotoxicity). 25925990

## OTHER REFERENCE LINKS

1. Recent References on Ixabepilone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ixabepilone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ixabepilone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ixabepilone)